# Usnic Acid

## OVERVIEW

### Introduction

Usnic acid is a furandione found uniquely in lichen that is used widely in cosmetics, deodorants, toothpaste and medicinal creams as well as some herbal products. Taken orally, usnic acid can be toxic and has been linked to instances of clinically apparent, acute liver injury.

### Background

Usnic acid is a dibenzo-furandione which is uniquely found in lichen (Usnea) species, which are distributed worldwide. In vitro usnic acid has antibacterial, antifungal and antiviral activities, and lichen extracts containing usnic acid have been used in folk medicine externally for wound healing and athlete’s foot and internally for sore throat, toothache and fever. Usnic acid has also found several commercial uses, largely in perfumery and cosmetic products, but also in medicinal creams. However, usnic acid appears to be toxic when taken orally in high doses and, for instance, can cause ataxia and paralysis in animals grazing on lichen contaminated crops and grains. Usnic acid has been purified and extensively studied in vitro and has been shown to uncouple oxidative phosphorylation in isolated mitochondria, which may account for its broad antimicrobial activity. Uncoupling of oxidative phosphorylation by decreasing the efficacy of energy use and causing increased thermogenesis has been proposed as an approach to treatment of obesity. However, this approach is potentially dangerous and has not been shown to be effective in causing weight loss other than by extreme toxicity. Nevertheless, usnic acid has been used in several commercial over-the-counter weight loss products.

### Hepatotoxicity

Several cases of clinically apparent acute liver injury have been attributed to commercial dietary supplements that contain usnic acid. “LipoKinetix” was one such supplement advertised as a weight loss and body building supplement. Each tablet contained sodium usniate (100 mg), norephedrine (25 mg), diiodothyronine (100 mg), yohimbine (3 mg) and caffeine (100 mg). The product has been linked to multiple instances of acute liver injury. The time to onset was 2 to 12 weeks and the clinical presentation resembled acute viral hepatitis with onset of fatigue and nausea, followed by jaundice. The pattern of serum enzyme elevations was hepatocellular, with marked elevations in serum ALT and minimal increases in alkaline phosphatase levels. Liver biopsy demonstrated acute hepatocellular necrosis and inflammation. Immunoallergic features (fever, rash and eosinophilia) were not common and autoantibodies were usually not present. Recovery was rapid with stopping the dietary supplement, but some cases were severe and led to acute liver failure and either death or need for emergency liver transplantation. Instances of acute hepatitis have also been reported with other multi-ingredient dietary supplements that contain usnic acid, but much more rarely than with LipoKinetix which was withdrawn from distribution after a FDA warning letter. Rare instances of hepatotoxicity have also been reported with use of lichen based teas known as Kombucha tea, but whether these were due to usnic acid or another contaminant of the tea was not shown.

Likelihood score (usnic acid): B (highly likely cause of clinically apparent liver injury).

Likelihood score (Kombucha tea): C (probable cause of clinically apparent liver injury).

### Mechanism of Injury

The hepatotoxicity of usnic acid is probably caused by uncoupling of oxidative phosphorylation in the liver, which can produce hepatocyte lysis and apoptosis and induces acute liver injury in animal models.

### Outcome and Management

Hepatotoxicity attributed usnic acid and products such as LipoKinetix is often clinically apparent, but is usually reversible with prompt discontinuation of the nutritional supplement. Usnic acid is a direct hepatotoxin and thus is unlikely to share cross sensitivity to liver injury with other agents.

Drug Class: Herbal and Dietary Supplements

## CASE REPORT

### Case 1. Acute liver failure due to usnic acid.

[Modified from case 1 of: Sanchez W, Maple JT, Burgart LJ, Kamath PS. Severe hepatotoxicity associated with use of a dietary supplement containing usnic acid. Mayo Clinic Proc 2006; 81: 541-4. PubMed Citation (https://www.ncbi.nlm.nih.gov/pubmed/16610575)].

A 38 year old woman developed fatigue, abdominal discomfort and jaundice 3 months after starting a multiingredient health supplement called UCP-1, which contained usnic acid. She was previously well and had no history of liver disease, alcohol abuse or risk factors for viral hepatitis. She had been on oral contraceptives and received a 2 week course of tinidazole 3 weeks before presentation. She was a fitness trainer at a health club in Asia, and she and her husband started taking the health supplement UCP-1 as an aid to body building in the recommended dose of 3 capsules 3 times daily, each capsule containing usnic acid (150 mg), L-carnitine (525 mg) and calcium pyruvate (1050 mg). She was hospitalized at which time her bilirubin was 23.0 mg/dL and serum aminotransferase levels markedly elevated (ALT 1636 U/L, AST 1536 U/L), while alkaline phosphatase levels were minimally increased (195 U/L) (Table). When she developed signs of hepatic encephalopathy, she was transferred to a liver transplant center in the United States. Over the next few days she developed worsening hepatic failure and underwent emergency liver transplantation. Tests for hepatitis A, B and C were negative as were autoimmune markers and tests for Wilson disease. The explant demonstrated massive necrosis and collapse. She recovered after transplant and was discharged a week later. Her husband had also used the nutritional supplement and, although not symptomatic, had marked elevations in serum aminotransferase values (ALT 1462 U/L, AST 451 U/L) with normal bilirubin levels. After stopping the supplement, his serum liver tests began to improve and were normal four months later.

#### Key Points

Medication: | UCP-1 (Usnic acid: ~1350 mg daily)
Pattern: | Hepatocellular (R=25.1)
Severity: | 5+ (acute liver failure, liver transplantation)
Latency: | 3 months
Recovery: | None
Other medications: | Oral contraceptives, tinidazole (an antiprotozoal agent similar to metronidazole)

#### Laboratory Values

Time After Starting | Time After Stopping | ALT (U/L) | Alk P (U/L) | Bilirubin (mg/dL) | Other
Pre | Pre | Started UCP-1
3 months | Few Days | 1636 | 195 | 23.0 | Protime 22.7 seconds
| ~1 week | 884 | 113 | 38.8 | INR=3.9
| ~2 weeks | Emergency liver transplantation
Normal Values | | <40 | <120 | <1.2

#### Comment

Usnic acid taken as a weight loss supplement has been associated with at least a dozen published cases of acute liver injury which, as in this case, can be severe, leading to acute liver failure and death or need for emergency liver transplantation. The fact that both husband and wife developed liver injury while on UCP-1 is in favor of its role in causing the injury, but they also shared common exposures and therefore the episode could also be due to common infectious agent. Nevertheless, the clinical presentation and course were entirely compatible with usnic acid associated hepatotoxicity.

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Usnic Acid – Generic

DRUG CLASS

Herbal and Dietary Supplements

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NUMBER | MOLECULAR FORMULA | STRUCTURE
Usnic Acid | 125-46-2 | C18-H16-O7 | Usnic Acid Chemical Structure

## ANNOTATED BIBLIOGRAPHY

References updated: 25 April 2018

Zimmerman HJ. Unconventional drugs. Miscellaneous drugs and diagnostic chemicals. In, Zimmerman, HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott,1999: pp. 731-4. (Expert review of hepatotoxicity published in 1999; unconventional drugs including Kombucha tea are discussed, but not usnic acid).
Seeff L, Stickel F, Navarro VJ. Hepatotoxicity of herbals and dietary supplements. In, Kaplowitz N, DeLeve LD, eds. Drug-induced liver disease. 3rd ed. Amsterdam: Elsevier, 2013, pp. 631-58. (Review of hepatotoxicity of herbal and dietary supplements [HDS]; usnic acid is listed as a cause of acute liver failure and was a component of Lipokinetix, a commercial product that has been withdrawn from the market).
Usnea. In, PDR for Herbal Medicines. 4th ed. Montvale, New Jersey: Thomson Healthcare Inc. 2007: pp. 867-8. (Compilation of short monographs on herbal medications and dietary supplements).
Perron AD, Patterson JA, Yanofsky NN. Kombucha “mushroom” hepatotoxicity. Ann Emerg Med 1995; 26: 660-1. (53 year old man developed fever, rash and abdominal cramping 4 weeks after starting and 2 weeks after stopping Kombucha tea [bilirubin normal, ALT 285 U/L, Alk P 168 U/L], resolving 1 month later). 7486385
Centers for Disease Control. Unexplained severe illness possibly associated with consumption of Kombucha tea – Iowa, 1995. MMWR 1995; 44: 892-900. (Two patients from a rural town in Iowa developed severe unexplained illness [lactic acidosis and cardiopulmonary collapse] after taking Kombucha tea for 2 months; cause was not identified). 7476846
Srinivasan R, Smolinske S, Greenbaum D. Probable gastrointestinal toxicity of Kombucha tea: is this beverage healthy or harmful? J Gen Intern Med 1997; 12: 643-4. (55 year old woman with history of heavy alcohol use developed jaundice 2 months after starting a daily intake of Kombucha tea [bilirubin 5.3 mg/dL, ALT 585 U/L, Alk P 203 U/L], resolving within 7 weeks of stopping; 3 other patients developed symptoms of toxicity without liver abnormalities while drinking Kombucha tea). 9346462
Ingolfsdottir K. Usnic acid. Phytochemistry 2002; 61: 729-36. (Usnic acid is a lichen metabolite used in creams, toothpaste, deodorants and as a preservative; also has antimicrobial activity and recently promoted as weight loss agent; toxic in high doses, it can cause paralysis, ataxia and acidosis). 12453567
Favreau JT, Ryu ML, Braunstein G, Orshansky G, Park SS, Coody GL, Love LA, Fong TL. Severe hepatotoxicity associated with the dietary supplement LipoKinetix. Ann Intern Med 2002; 136: 590-5. (7 patients, 4 women and 3 men, ages 20-32 years, developed symptoms and jaundice [n=5] or liver test abnormalities [n=2], 1-12 weeks after starting LipoKinetix [norephedrine, usniate, diiodothyronine, yohimbine, caffeine] for weight loss [peak bilirubin 2.2-14.6 mg/dL, ALT 438-14,150 U/L], resolving in 1-3 months of stopping). 11955027
'Dietary supplement' warning. FDA Consum 2002; 36: 4. (FDA warning of the potential hepatotoxicity of usnic acid containing weight loss products). 11989472
Lewis JD, Strom BL. Balancing safety of dietary supplements with the free market. Ann Intern Med 2002; 136: 616-8. (Editorial on Favreau [2002] regarding Lipo-Kinetix and the regulation of dietary supplements in the US). 11955030
Estes JD, Stolpman D, Olyaei A, Corless CL, Ham JM, Schwartz JM, Orloff SL. High prevalence of potentially hepatotoxic herbal supplement use in patients with fulminant hepatic failure. Arch Surg 2003; 138: 852-8. (Among 20 patients undergoing liver transplantation for acute liver failure during 2001-2, 10 were potentially caused by herbals: 3 due to Ma Huang, 3 kava, 2 LipoKinetix [usnic acid], 1 chaparral, 1 skullcap and 2 miscellaneous Chinese herbs). 12912743
Russo MW, Galanko JA, Shrestha R, Fried MW, Watkins P. Liver transplantation for acute liver failure from drug-induced liver injury in the United States. Liver Transpl 2004; 10: 1018-23. (Among ~50,000 liver transplants reported to UNOS between 1990 and 2002, 270 [0.5%] were done for drug induced acute liver failure, including 7 [5%] due to herbal medications; usnic acid was not specifically mentioned). 15390328
Durazo FA, Lassman C, Han SH, Saab S, Lee NP, Kawano M, Saggi B, et al. Fulminant liver failure due to usnic acid for weight loss. Am J Gastroenterol 2004; 99: 950-2. (28 year old woman developed nausea and fatigue 2 weeks after starting usnic acid and, despite stopping it, developed jaundice, confusion and hepatic failure requiring liver transplantation [bilirubin 28 mg/dL, ALT 449 U/L, AST 1016 U/L, INR 4.6]; the explant demonstrated massive necrosis). 15128366
Neff GW, Reddy KR, Durazo FA, Meyer D, Marrero R, Kaplowitz N. Severe hepatotoxicity associated with the use of weight loss diet supplements containing ma huang or usnic acid. J Hepatol 2004; 41: 1062-4. (Summary report of 12 patients who developed liver injury after taking herbal weight loss products including two who were taking Lipokinetix [bilirubin 20 and 35 mg/dL, ALT 1500 and 1420, Alk P not given], one of whom recovered and one underwent transplantation). 15582145
Willett KL, Roth RA, Walker L. Workshop overview: Hepatotoxicity assessment for botanical dietary supplements. Toxicol Sci 2004; 79: 4-9. (Summary of a workshop on the hepatotoxicity of botanicals focusing upon mechanisms of hepatic injury and means of prediction and prevention). 14976355
Han D, Matsumaru K, Tettori D, Kaplowitz N. Usnic acid-induced necrosis of cultured mouse hepatocytes: inhibition of mitochondrial function and oxidative stress. Biochem Pharmacol 2004; 67: 439-51. (Usnic acid caused necrosis of isolated mouse hepatocytes probably by uncoupling of electron transport in mitochondria, oxidative stress and depletion of glutathione). 15037196
Hsu LM, Huang YS, Chang FY, Lee SD. ‘Fat burner’ herb, usnic acid, induced acute hepatitis in a family. J Gastroenterol Hepatol 2005; 20: 1138-9. (3 sisters with toxicity from herbal “fat burner” consisting of soybean extract and usnic acid; 36 year old woman had abdominal pain 2 weeks after starting herbal [bilirubin normal, ALT 442 U/L, Alk P 217 U/L], resolving within 6 weeks; 32 year old sister developed jaundice after 4 weeks of use [bilirubin 29 mg/dL, ALT 778 U/L, Alk P 118 U/L, INR 2.6], resolving in 4 months; third sister stopped the herbal after 3 days because of fatigue). 15955234
Arneborn P, Jansson A, Böttiger Y. [Acute hepatitis in a woman after intake of slimming pills bought via Internet]. Lakartidningen 2005; 102: 2071-2. Swedish. (20 year old overweight woman developed nausea followed by jaundice 4 weeks after starting a weight loss agent [Termoxical, containing usnic acid] purchased over the Internet [bilirubin 4.9 mg/dL, ALT 1320 U/L, Alk P 198 U/L], resolving within a month of stopping). 16097177
Sanchez W, Maple JT, Burgart LJ, Kamath PS. Severe hepatotoxicity associated with use of a dietary supplement containing usnic acid. Mayo Clinic Proc 2006; 81: 541-4. (Two cases: 38 year old woman developed jaundice 3 months after starting UCP-1 in a dose of 1350 mg daily [bilirubin 23.0 mg/dL, ALT 1636 U/L, Alk P 195 U/L, protime 22.7 sec], progressing to hepatic failure and successful liver transplantation [Case 1]; 38 year old husband of previous case developed back pain 3 months after starting UCP-1 [bilirubin 0.6 mg/dL, ALT 1462 U/L], with rapid resolution on stopping and normal values 4 months later). 16610575
Chitturi S, Farrell GC. Hepatotoxic slimming aids and other herbal hepatotoxins. J Gastroenterol Hepatol 2008; 23: 366-73. (Review of hepatotoxicity of herbal medications focusing upon those used for weight loss, including nitrosofenfluramine, usnic acid, ephedra, germander, skullcap and green tea). 18318821
Foti RS, Dickmann LJ, Davis JA, Greene RJ, Hill JJ, Howard ML, Pearson JT, et al. Metabolism and related human risk factors for hepatic damage by usnic acid containing nutritional supplements. Xenobiotica 2008; 38: 264-80. (In vitro analyses of effects of usnic acid on hepatic cytochrome P450 enzymes found that it was a potent inhibitor of CYP 2C19 and 2C9, suggesting that it could cause significant drug-herb interactions). 18274956
Guo L, Shi Q, Fang JL, Mei N, Ali AA, Lewis SM, Leakey JE, Frankos VH. Review of usnic acid and Usnea barbata toxicity. J Environ Sci Health C Environ Carcinog Ecotoxicol Rev 2008; 26: 317-38. (Usnea extracts have been used in traditional Chinese medicine for centuries as an antimicrobial and for other uses, including in cosmetics, food, toothpaste and mouthwash; in vitro, it has mitochondrial uncoupling properties and was therefore used for weight loss; FDA has received 21 adverse event reports including 1 death attributed to dietary supplements containing usnic acid [LipoKinetix and UCP-1] and 12 cases have appeared in the literature, leading to warnings and recommendations for it to be withdrawn). 19034791
Chalasani N, Fontana RJ, Bonkovsky HL, Watkins PB, Davern T, Serrano J, Yang H, Rochon J; Drug Induced Liver Injury Network (DILIN). Causes, clinical features, and outcomes from a prospective study of drug-induced liver injury in the United States. Gastroenterology 2008; 135: 1924-34. (Among 300 cases of drug induced liver disease in the US collected between 2004 and 2008, 9% of cases were attributed to herbal medications, usnic acid was not listed). 18955056
Navarro VJ. Herbal and dietary supplement hepatotoxicity. Semin Liver Dis 2009; 29: 373-82. (Overview of the regulatory environment, clinical patterns, and future directions in research with HDS including traditional Chinese herbal medicines and usnic acid). 19826971
Jacobsson I, Jönsson AK, Gerdén B, Hägg S. Spontaneously reported adverse reactions in association with complementary and alternative medicine substances in Sweden. Pharmacoepidemiol Drug Saf 2009; 18: 1039-47. (Review of 778 spontaneous reports of adverse reactions to herbals to Swedish Registry does not mention usnic acid specifically). 19650152
SungHee Kole A, Jones HD, Christensen R, Gladstein J. A case of Kombucha tea toxicity. J Intensive Care Med 2009; 24 205-7. (22 year old man with HIV infection developed fever and agitation a day after drinking a large amount of Kombucha tea, presenting with lactic acidosis and fever [bilirubin and Alk P normal, ALT 57 U/L, lactate 12.9 mmol/L, arterial pH 7.21], resolving within 72 hours with supportive care only). 19460826
Reuben A, Koch DG, Lee WM; Acute Liver Failure Study Group. Drug-induced acute liver failure: results of a U.S. multicenter, prospective study. Hepatology 2010; 52: 2065-76. (Among 1198 patients with acute liver failure enrolled in a US prospective study between 1998 and 2007, 133 [11%] were attributed to drug induced liver injury, of which 12 [9%] were due to herbals, including 2 due to usnic acid). 20949552
Stickel F, Kessebohm K, Weimann R, Seitz HK. Review of liver injury associated with dietary supplements. Liver Int 2011; 31: 595-605. (Review of current understanding of liver injury from herbals and dietary supplements focusing upon herbalife and hydroxycut products, green tea, usnic acid, Noni juice, Chinese herbs, vitamin A and anabolic steroids). 21457422
Yellapu RK, Mittal V, Grewal P, Fiel M, Schiano T. Acute liver failure caused by 'fat burners' and dietary supplements: a case report and literature review. Can J Gastroenterol 2011; 25: 157-60. (28 year old woman developed jaundice one month after starting two "fat burners" [Somalyz and Lipolyz] containing usnic acid as an aid to body building [bilirubin 4.8 mg/dL, ALT 1220 U/L, Alk P 111 U/L, INR 2.6], with rapid progression to acute liver failure requring liver transplantation; the explant showed massive necrosis). 21499580
Bunchorntavakul C, Reddy KR. Review article: herbal and dietary supplement hepatotoxicity. Aliment Pharmacol Ther 2013; 37: 3-17. (Systematic review of literature on HDS associated liver injury mentions that usnic acid has been implicated in causing clinically apparent hepatotoxicity). 23121117
Björnsson ES, Bergmann OM, Björnsson HK, Kvaran RB, Olafsson S. Incidence, presentation and outcomes in patients with drug-induced liver injury in the general population of Iceland. Gastroenterology 2013; 144: 1419-25. (In a population based study of drug induced liver injury from Iceland, 96 cases were identified over a 2 year period, including 15 attributed to herbals or dietary supplements, but none were linked to usnic acid containing products specifically). 23419359
Licata A, Macaluso FS, Craxì A. Herbal hepatotoxicity: a hidden epidemic. Intern Emerg Med 2013; 8: 13-22. (Review and commentary on herbal hepatotoxicity with specific focus on ephedra, germander, kava, chapararal, black cohosh, greater celandine, usnic acid, and Herbalife, Hydroxycut and LipoKinetix products). 22477279
Navarro VJ, Seeff LB. Liver injury induced by herbal complementary and alternative medicine. Clin Liver Dis 2013; 17: 715-35. (Review of HDS induced liver injury including regulatory problems, difficulties in diagnosis and causality assessment, includes specific comments on usnic acid). 24099027
de Oliveira AV, Rocha FT, Abreu SR. Acute liver failure and self-medication. Arq Bras Cir Dig 2014; 27: 294-7. (Review of published literature on acute liver failure associated with self-medication identified cases related to acetaminophen, GTE, linoleic acid, rhamnus purshianus [Fitosoja] and usnic acid). 25626943
Navarro VJ, Barnhart H, Bonkovsky HL, Davern T, Fontana RJ, Grant L, Reddy KR, et al. Liver injury from herbals and dietary supplements in the U.S. Drug-Induced Liver Injury Network. Hepatology 2014; 60: 1399-408. (Among 85 cases of HDS associated liver injury [not due to anabolic steroids] enrolled in a US prospective study between 2004 and 2013, the single most commonly implicated herbal agent was green tea extract; usnic acid not specifically mentioned or listed). 25043597
Seeff LB, Bonkovsky HL, Navarro VJ, Wang G. Herbal products and the liver: a review of adverse effects and mechanisms. Gastroenterology 2015; 148: 517-32. (Extensive review of possible beneficial as well as harmful effects of herbal products on the liver; no specific discussion of usnic acid). 25500423
Stickel F, Shouval D. Hepatotoxicity of herbal and dietary supplements: an update. Arch Toxicol. 2015; 89: 851-65. (Extensive review of liver injury due to HDS discusses usnic acid which was introduced as a potential weight loss agent because of its activity in uncoupling oxidative phosphorylation, but which also can cause mitochondrial injury and has been implicated in cases of acute hepatitis which can be severe and has resulted in fatalities, leading to FDA warnings and its withdrawal from the market). 25680499
Chalasani N, Bonkovsky HL, Fontana R, Lee W, Stolz A, Talwalkar J, Reddy KR, et al.; United States Drug Induced Liver Injury Network. Features and outcomes of 899 patients with drug-induced liver injury: The DILIN Prospective Study. Gastroenterology 2015; 148: 1340-52. (Among 899 cases of drug induced liver injury enrolled in a prospective database between 2004 and 2012, HDS were implicated in 145 [16%], the single major herbal cause being green tea extract; usnic acid was not discussed). 25754159
Zheng EX, Navarro VJ. Liver injury from herbal, dietary, and weight loss supplements: a review. J Clin Transl Hepatol 2015; 3: 93-8. (Review of literature on liver injury due to HDS products used for weight loss, focusing upon the case series of liver injury attributed to green tea as well as the commercial products that appear to contain it such as Herbalife and Hydroxycut, the injury of which was predominantly hepatocellular [acute hepatitis-like] and had a significant mortality rate). 26357638
Gedela M, Potu KC, Gali VL, Alyamany K, Jha LK. A case of hepatotoxicity related to Kombucha tea consumption. S D Med 2016; 69: 26-8. (58 year old woman developed jaundice 1 month after starting daily Kombucha tea use [bilirubin 4.1 rising to 7.5 mg/dL, ALT 330 U/L, Alk P 630 U/L], resolving within 1 month of stopping the herbal tea). 26882579
García-Cortés M, Robles-Díaz M, Ortega-Alonso A, Medina-Caliz I, Andrade RJ. Hepatotoxicity by dietary supplements: A tabular listing and clinical characteristics. Int J Mol Sci 2016; 17. pii: E537. (Listing of published cases of liver injury from HDS products, including cases of hepatitis and acute liver failure due to usnic acid).27070596
Brown AC. Liver toxicity related to herbs and dietary supplements: Online table of case reports. Part 2 of 5 series. Food Chem Toxicol 2017; 107 (Pt A): 472-501. (Description of an online compendium of cases of liver toxicity attributed to HDS products, lists at least 46 published cases of green tea associated liver injury and concludes that green tea may warrant a warning label). 27402097
Wong LL, Lacar L, Roytman M, Orloff SL. Urgent liver transplantation for dietary supplements: an under-recognized problem. Transplant Proc 2017; 49: 322-5. (Among 2048 adult liver transplants recipients enrolled in the Scientific Registry of Transplant Recipients [SRTR] between 2003 and 2015, 625 were done for acute hepatic necrosis due to drug induced liver injury, half being due to acetaminophen and the 4th most frequent cause [n=21] being HDS products, although none were specifically listed as containing usnic acid). 28219592
Vega M, Verma M, Beswick D, Bey S, Hossack J, Merriman N, Shah A, et al; Drug Induced Liver Injury Network (DILIN). The incidence of drug- and herbal and dietary supplement-induced liver injury: preliminary findings from gastroenterologist-based surveillance in the population of the State of Delaware. Drug Saf 2017; 40: 783-7. (A prospective, population based registry of cases of drug induced liver injury occurring in Delaware during 2014, identified 20 cases [2.7 per 100,000] overall, including 6 due to HDS products, all of which were proprietary multiingredient products, but none listed usnic acid as a component). 28555362

## OTHER REFERENCE LINKS

1. Recent References on Usnic Acid: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=Usnic+Acid+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D%3A%222999/12/31%22%5BEDat%5D))
2. Trials on Usnic Acid: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Usnic+Acid)